# Tucatinib

## OVERVIEW

### Introduction

Tucatinib is tyrosine kinase inhibitor that targets the human epidermal growth factor receptor 2 (HER2) and is used in combination with other antineoplastic agents in the treatment of refractory, advanced or metastatic HER2 positive breast and colorectal cancer. Serum aminotransferase elevations are common during therapy with tucatinib, but it has not been linked to episodes of clinically apparent liver injury with jaundice.

### Background

Tucatinib (too ka’ ti nib) is an orally available small molecule inhibitor of the human epidermal growth factor receptor 2 (HER2), a tyrosine kinase that is overexpressed in some cancers and leads to excessive cell growth and proliferation. HER2 is an oncogenic driver found overexpressed in 15% to 20% of cases of breast cancer and more rarely in other solid tumors such as colorectal cancer. In a large randomized, double-blind placebo controlled trial, the addition of tucatinib to trastuzumab and capecitabine was found to induce objective responses in 60% of patients with refractory metastatic or advanced unresectable HER2 positive breast cancer, including patients with brain metastases. Tucatinib combined with trastuzumab and capecitabine was granted accelerated approval in the United States in 2020 for adults with advanced or metastatic HER2 positive breast cancer after failure of prior anti-HER2-based regimens. Tucatinib unlike monoclonal antibodies penetrates the blood-brain barrier, perhaps accounting for its efficacy in treating brain metastases refractory to monoclonal antibody based anti-HER2 therapies. In 2023, indications for tucatinib were extended to refractory HER2 positive advanced unresectable metastatic colorectal cancers in combination with trastuzumab alone. Tucatinib is available in tablets of 50 and 150 mg under the brand name Tukysa. The recommended dose is 300 mg orally twice daily until disease progression or unacceptable toxicity. Side effects are common and arise in almost all patients treated with tucatinib combined with trastuzumab and capecitabine and lead to dose modification or interruptions in at least 20% of treated patients and permanent discontinuation in 6%. Common side effects include diarrhea, palmar-plantar erythrodysesthesia (hand-foot syndrome), nausea and vomiting, abdominal pain, fatigue, myalgia, arthralgia, cough, dyspnea, fever, lymphopenia, anemia, and aminotransferase elevations. Uncommon but potentially severe adverse events include severe diarrhea, hepatotoxicity, and embryo-fetal toxicity. Of course, some of the toxicity associated with tucatinib therapy may be due to the concurrent use of trastuzumab and capecitabine.

### Hepatotoxicity

In the prelicensure clinical trials of tucatinib in combination with trastuzumab and capecitabine in patients with metastatic and unresectable HER2 positive breast cancer, liver test abnormalities were frequent although usually self-limited and mild. Some degree of ALT elevations arose in 46% of those receiving tucatinib vs 27% treated with trastuzumab and capecitabine alone. Peak ALT levels rose to above 5 times the upper limit of normal (ULN) in 8% of the tucatinib treated subjects but in less than 1% of controls receiving trastuzumab and capecitabine alone. In a controlled trial enrolling 612 patients with breast cancer, 9 tucatinib treated patients developed ALT elevations and hyperbilirubinemia. Upon further evaluation, however, none of these cases of suspected significant liver injury were considered due to tucatinib, all patients having other possible reasons for liver injury and jaundice. There were no cases of tucatinib-associated liver failure or hepatotoxicity leading to death in any of the prelicensure studies. The product label for tucatinib recommends monitoring for routine liver tests before and every 3 weeks during therapy, and as clinically indicated.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from tucatinib is unknown, but the pattern of abnormalities suggests direct liver injury. Tucatinib is metabolized in the liver via the cytochrome P450 system, largely CYP 2C8 and 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce these CYP enzyme reactivities. Tucatinib is also an inhibitor CYP 3A4 and P-glycoprotein and can increase the toxicity of drugs that are substrates for these enzymes and transporters.

### Outcome and Management

The product label for tucatinib recommends monitoring for routine liver tests before and every 3 weeks during treatment. Serum aminotransferase elevations above 5 times ULN or bilirubin above 3 times ULN should lead to dose reduction or temporary cessation of tucatinib therapy and careful monitoring. If serum aminotransferase levels and bilirubin improve to normal or near normal levels, tucatinib can be restarted at a lower dose. In patients with ALT elevations above 20 times ULN or any aminotransferase elevations with jaundice or symptoms of liver injury, tucatinib should be promptly discontinued and not restarted. Cross sensitivity to liver injury is uncommon among the antineoplastic, small molecule enzyme and receptor inhibitors, but there is no information on shared adverse event sensitivity of tucatinib with other antineoplastic tyrosine kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tucatinib – Tukysa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tucatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tucatinib | 937263-43-9 | C26-H24-N8-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 09 September 2023

Abbreviations: HER2, human epidermal growth factor receptor 2.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss tucatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213411Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of tucatinib given in combination with trastuzumab and capecitabine (T+C) as therapy of metastatic refractory HER2+ breast cancer; states that median overall survival was longer with tucatinib+T+C than with placebo+T+C controls [22 vs 17 months] and adverse event rates were similar in both groups but hepatic events [the combination of ALT, AST, and bilirubin abnormalities] occurred in 39% on tucatinib vs 23% in controls, and 9 subjects had both ALT elevations and jaundice, but none were considered due to therapy as other causes were found so that there were no cases of hepatotoxicity leading to liver failure or death).
Murthy R, Borges VF, Conlin A, Chaves J, Chamberlain M, Gray T, Vo A, et al. Tucatinib with capecitabine and trastuzumab in advanced HER2-positive metastatic breast cancer with and without brain metastases: a non-randomised, open-label, phase 1b study. Lancet Oncol. 2018;19:880-888. (Among 60 patients with advanced HER2+ metastatic breast cancer treated with tucatinib with either trastuzumab [T] or capecitabine [C] or both [TC], the objective response rate was 61% with tucatinib+TC compared to 40% with tucatinib+T and 83% with tucatinib+C, while adverse events included diarrhea [67%], hand-foot syndrome [44%], fatigue [38%] and ALT elevations [12%], but there were no instances of clinically apparent liver injury with jaundice). 29804905
Murthy RK, Loi S, Okines A, Paplomata E, Hamilton E, Hurvitz SA, Lin NU, et al. Tucatinib, trastuzumab, and capecitabine for HER2-positive metastatic breast cancer. N Engl J Med. 2020;382:597-609. (Among 612 patients with refractory, HER2+ metastatic breast cancer enrolled in a randomized controlled trial of addition of tucatinib vs placebo to the combination of trastuzumab and capecitabine, the overall survival at 2 years was 45% vs 27% with responses in brain metastases; adverse events were common in both groups [99% vs 97%], but more frequent with tucatinib were diarrhea [81% vs 53%], hand-foot syndrome [63% vs 53%], and ALT elevations [20% vs 7%], particularly values above 5 times ULN [5% vs 0.5%] and one patient developed ALT elevations [134 U/L] with jaundice [bilirubin 2.6 mg/dL] but recovered with dose reduction and was able to continue therapy without recurrence). 31825569
Two drugs for advanced HER2-positive breast cancer (Enhertu and Tukysa). Med Lett Drugs Ther. 2020;62:182-184. (Concise summary of the mechanism of action, clinical efficacy, adverse effects, and costs of tucatinib shortly after its approval as therapy with trastuzumab and capecitabine for refractory, advanced HER2+ breast cancer, mentions that it can cause severe hepatotoxicity and routine liver tests should be monitored before and every 3 weeks during treatment). 33429416
Shah M, Wedam S, Cheng J, Fiero MH, Xia H, Li F, Fan J, et al. FDA approval summary: tucatinib for the treatment of patients with advanced or metastatic HER2-positive breast cancer. Clin Cancer Res. 2021;27:1220-1226. (Summary of the data on efficacy and safety of tucatinib that supported its approval as therapy of refractory, advanced or metastatic HER2+ breast cancer mentions that hepatotoxicity was a safety signal of concern and while tucatinib therapy was associated with a high rate of abnormal ALT, AST and bilirubin levels, there were no cases of confirmed clinically apparent drug induced liver injury or liver failure that could be attributed to tucatinib therapy). 33055172
Curigliano G, Mueller V, Borges V, Hamilton E, Hurvitz S, Loi S, Murthy R, et al. Tucatinib versus placebo added to trastuzumab and capecitabine for patients with pretreated HER2+ metastatic breast cancer with and without brain metastases (HER2CLIMB): final overall survival analysis. Ann Oncol. 2022;33:321-329. (Final results from the pivotal randomized controlled trial of tucatinib vs placebo added to trastuzumab and capecitabine in 612 adults with refractory HER+ metastatic breast cancer [Murthy 2020] reported an overall survival at 2 years of 24.7 vs 19.2 months and that “rates of liver laboratory abnormalities and diarrhea did not increase with additional follow up”). 34954044
Strickler JH, Cercek A, Siena S, André T, Ng K, Van Cutsem E, Wu C, et al.; MOUNTAINEER investigators. Tucatinib plus trastuzumab for chemotherapy-refractory, HER2-positive, RAS wild-type unresectable or metastatic colorectal cancer (MOUNTAINEER): a multicentre, open-label, phase 2 study. Lancet Oncol. 2023;24:496-508. (Among 84 patients with refractory, unresectable or metastatic HER2+ colorectal cancer treated with tucatinib and trastuzumab, the objective response rate was 38%, while 95% developed at least one adverse event including ALT elevations in 5 patients [6%] which were above 5 times ULN in 3 [4%], but there were no episodes of clinically apparent liver injury with jaundice). 37142372
In brief: A second indication for tucatinib (Tukysa). Med Lett Drugs Ther. 2023;65:e37-e38. (Concise summary of the mechanism of action, clinical efficacy, adverse effects, and costs of tucatinib shortly after its approval as therapy with trastuzumab for HER2+ advanced colorectal cancer, mentions that “severe hepatotoxicity can occur” and routine liver tests should be monitored during treatment). 36877245

## OTHER REFERENCE LINKS

Recent References on Tucatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tucatinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tucatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tucatinib)